# Gymnema

## OVERVIEW

### Introduction

Gymnema sylvestre is perennial tree-climbing vine with small yellow flowers, the leaves of which have been used extensively in traditional medicine for many conditions including diabetes, hyperlipidemia, obesity, arthritis, liver diseases, malaria, dysentery, and general wellbeing. Gymnema has recently become a popular in the United States, as extracts of its leaves have been promoted for blood glucose control and weight loss. There have been isolated rare reports of liver injury from herbal products containing Gymnema sylvestre, but attribution to the herb was usually weak.

### Background

Gymnema sylvestre is a flowering, perennial, tree-climbing vine native to Asia, Africa and Australia, the leaves, fruits, and seeds of which have been used extensively in traditional medicine for many conditions including diabetes, dyslipidemia, obesity, arthritis, liver diseases, malaria, dysentery, and general wellbeing. In vitro and in vivo analysis of Gymnema sylvestre leaf extracts have shown hypoglycemic effects which have led to its use in diabetes and in weight loss control. Chemical analyses have demonstrated more than 50 components, the most distinctive being multiple gymnemic acids that are triterpene saponins. Other components include flavones, anthraquinones, alkaloids, phytin, resins, and tannins. In vitro, gymnemic acids have been shown to bind to and inhibit human, sweet taste receptors, and both animal and human studies indicate the ingredients can suppress taste response to sweet substances. Gymnema extracts may have other antidiabetic actions, such as enhanced insulin secretion and inhibition of glucose absorption as well as cholesterol-lowering, antioxidant, antiinflammatory, antibacterial, and antineoplastic activities. Several trials of Gymnema extracts in humans have shown mild decreases in fasting plasma glucose levels accompanied by increases in hemoglobin A1c levels, but the overall effectiveness in the treatment of diabetes has not been shown, and Gymnema has not been approved as therapy of any medical condition in the United States. Extracts of Gymnema sylvestre are available over-the-counter in various forms and concentrations including raw powders or capsules alone or in combination with other herbal products or dietary supplements. The typical recommended dose is 400 mg three times daily, but some commercial products recommend as much as several grams daily. At present there is little standardization of purity and concentration of extracts in Gymnema products. Side effects of conventional doses are uncommon but may include nausea, abdominal discomfort, diarrhea, headaches, and rash. Its long term safety has not been well documented in humans.

### Hepatotoxicity

In small rather short term clinical studies of different preparations and concentrations of Gymnema sylvestre, adverse side effects were usually described as uncommon, unrelated to therapy, and minimal with no changes in serum ALT, AST, GGT or bilirubin levels. The effects of long term use and of higher doses, however, have not been assessed in humans. Over the last 25 years, there have been rare, isolated reports of clinically apparent liver injury in patients taking Gymnema sylvestre (Case 1). On the other hand, large case series and literature searches do not mention it as a potential cause of herb induced liver injury.

Likelihood score: D (possible rare cause of clinically apparent liver injury).

### Mechanism of Injury

Gymnema sylvestre has multiple constituents and the chemical compounds that are possibly responsible for liver injury are not known. The clinical features of the described cases of Gymnema sylvestre liver injury suggest that it is immunologically mediated. Cases may be more frequent and more severe in patients receiving higher doses or with preexisting liver disease.

### Outcome and Management

Liver injury reported from Gymnema sylvestre has been self-limited in course and chronic injury has not been clearly described. At issue with most cases has been the possible role of contaminants, other acute causes (other drugs being taken, gallstones), or worsening preexisting liver disease.

Drug Class: Herbal and Dietary Supplements

Other names: Gymnema, Australian Cow Plant, Periploca, Miracle Plant, Gumar (Hindi for “sugar destroyer”).

## CASE REPORT

### Case 1. Acute liver injury with jaundice attributed to herbal tea containing Gymnema sylvestre.(1)

A 60 year old woman developed weakness, fatigue, loss of appetite, weight loss and jaundice 7 days after starting an Gymnema sylvestre in the form of an herbal tea, taken 3 days daily for type 2 diabetes. After 3 days of symptoms, she stopped the herbal tea and a week later of worsening symptoms sought medical care. She had no history of liver disease, alcohol abuse, risk factors for viral hepatitis, or drug allergies. Her only other medication was acetazolamide for glaucoma that she had taken for two years. Physical examination revealed obesity (BMI 33 kg/m^2^) and jaundice. Laboratory tests revealed a bilirubin of 15.6 (direct 9.0) mg/dL, ALT 760 U/L, AST 657 U/L, alkaline phosphatase 160 U/L, and GGT 273 U/L (R=16). Tests for acute hepatitis A, B, C and E were negative as were antibodies to Epstein Barr virus and cytomegalovirus. Autoantibodies including ANA, SMA and ANA were also negative. Abdominal ultrasound showed mild hepatomegaly and steatosis, but no evidence of biliary dilatation or gallstones. Prednisone was started in a dose of 60 mg daily. A liver biopsy, however, showed an acute hepatitis with ductular reaction on top of macro- and micro-vesicular steatosis with changes interpreted as due to drug induced liver injury. She was discharged on tapering doses of prednisone. In follow up, corticosteroids were discontinued, and liver tests fell and remained in the normal range.

#### Key Points

Medication: | Gymnema sylvestre in herbal tea (unknown dose) for 10 days
Pattern: | Hepatocellular (R=16.0)
Severity: | Moderate—hospitalized (3+)
Latency: | 7 days to symptoms, 17 to medical presentation
Recovery: | Within 6 months
Other medications: | Acetazolamide

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Comments
0 | Pre | Started herbal tea of G. sylvestre [3 times daily]
7 days | Pre | Symptoms of fatigue and poor appetite
10 days | 0 | Jaundice, stopped herbal tea
17 days | 7 | 760 | 160 | 15.6 | Hospital admission
| 8-14 days | | | | Ultrasound, CT, Liver biopsy
| | | | | Prednisone, gradual tapered
6 months | | 25 | 36 | 0.5
Upper Limit of Normal | | 31 | 104 | 1.2

#### * Standard values

Comment

A 60 year old woman with type 2 diabetes developed a moderately severe acute hepatocellular injury within 1 to 2 weeks of starting an herbal tea containing Gymnema sylvestre extract. She was treated with prednisone initially, but it was withdrawn after liver biopsy findings suggested drug induced liver injury rather than autoimmune hepatitis. Other causes of acute hepatitis were adequately excluded. However, liver injury from herbal tea is exceedingly rare and no similar cases attributable to Gymnema have been reported. The short latency to onset and severity were also unexpected from herbal tea induced liver injury. Acetazolamide can cause acute liver injury, but usually within a few weeks of starting and frequently accompanied Stevens Johnson syndrome and prominence of immunoallergic symptoms. Gall bladder disease can also present as an acute hepatitis initially, but imaging demonstrated no evidence of gall stones or biliary obstruction. Finally, the possibility of a spontaneous onset of autoimmune hepatitis must be considered, which was indeed the initial diagnosis before a liver biopsy suggested otherwise. Because she received prednisone and had a clinical response, the diagnosis of spontaneous autoimmune hepatitis cannot be completely discounted without long term follow up. In this case, all liver tests were normal 6 months later when she was no longer taking prednisone. Thus, this report is reasonably convincing of liver injury due to Gymnema sylvestre and indicates that taking a history of exposure to herbal teas should be a part of the differential diagnosis of new onset acute liver injury of unclear cause.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Gymnema sylvestre – Generic

DRUG CLASS

Herbal and Dietary Supplements

Fact Sheet at MedlinePlus, NLM (https://medlineplus.gov/druginfo/natural/841.html)

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Gymnemic Acid I | 122168-40-5 | C43-H66-O14

## CITED REFERENCE

1 Shiyovich A, Sztarkier I, Nesher L. Toxic hepatitis induced by Gymnema sylvestre, a natural remedy for type 2 diabetes mellitus. Am J Med Sci. 2010;340:514-7.20856101

## ANNOTATED BIBLIOGRAPHY

References updated: 28 October 2024

Abbreviations: HDS, herbal and dietary supplements.

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott,1999: pp. 731-4. (Expert book on hepatotoxicity published in 1999; several herbal medications are discussed, but not Gymnema sylvestre).
Liu LU, Schiano TD. Hepatotoxicity of herbal medicines, vitamins and natural hepatotoxins. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 2nd ed. New York: Informa Healthcare USA, 2007, pp. 733-54. (Book on hepatotoxicity published in 2007 in which herbal and dietary supplements are discussed, but with no mention of Gymnema sylvestre).
Shanmugasundaram ER, Rajeswari G, Baskaran K, Rajesh Kumar BR, Radha Shanmugasundaram K, Kizar Ahmath B. Use of Gymnema sylvestre leaf extract in the control of blood glucose in insulin-dependent diabetes mellitus. J Ethnopharmacol. 1990;30:281-94. (Among 27 patients with insulin-dependent diabetes on insulin who were treated with Gymnema sylvestre for 6-8 months, fasting blood sugars were reduced [232 to 177 mg/dL] while not decreasing in an untreated group on insulin, and with this a decrease in insulin doses and HgbA1c [12.8 to 9.5%], and there were no “undesirable” side effects). 2259216
Baskaran K, Kizar Ahamath B, Radha Shanmugasundaram K, Shanmugasundaram ER. Antidiabetic effect of a leaf extract from Gymnema sylvestre in non-insulin-dependent diabetes mellitus patients. J Ethnopharmacol. 1990;30:295-300. (Among 22 patients with type 2 diabetes on conventional oral drugs who were treated with addition of Gymnema sylvestre [400 mg daily] for 18-20 months, fasting blood glucose and HbA1c levels decreased in all patients and serum lipids improved; no mention of adverse events but most patients also felt better, and 5 were able to stop their conventional antidiabetic medications). 2259217
Yeh GY, Eisenberg DM, Kaptchuk TJ, Phillips RS. Systematic review of herbs and dietary supplements for glycemic control in diabetes. Diabetes Care. 2003;26:1277-94. (Literature review of herbal therapies for glucose control in diabetes, identified 108 trials of 36 herbs and 9 vitamins or minerals, one herbal being Gymnema sylvestre which had been studied in 2 trials, both of which were positive but the evidence was “suggestive but inconclusive”; no mention of adverse events). 12663610
Al-Romaiyan A, Liu B, Asare-Anane H, Maity CR, Chatterjee SK, Koley N, Biswas T, et al. A novel Gymnema sylvestre extract stimulates insulin secretion from human islets in vivo and in vitro. Phytother Res. 2010;24:1370-6. (Among 11 adults with type 2 diabetes treated with a high molecular weight extract of G. sylvestre [500 mg] twice daily before meals for 60 days, fasting blood glucose levels improved in 10 [mean levels falling from 162 to 119 mg/dL] with no change in body weight, and accompanied by increases in mean serum insulin [24 to 32 μM/mL] and C-peptide [298 to 447 pmol/L] suggesting herb induced increases in insulin secretion; no mention of adverse events or serum ALT or AST levels). 20812281
Kumar SN, Mani UV, Mani I. An open label study on the supplementation of Gymnema sylvestre in type 2 diabetics. J Diet Suppl. 2010;7:273-82. (Among 58 “free-living” adults with type 2 diabetes self-assigned to receive Gymnema silvestre or no therapy for 3 months, treated patients reported improvements in fatigue, polyuria, and hunger and had mild weight loss and improvements in fasting blood glucose [189 to 163 mg/dL] and HbA1c [9.6 to 8.6] levels, while values worsened in the control group; serum ALT and AST levels were normal in both groups and did not change). 22432517
Al-Romaiyan A, King AJ, Persaud SJ, Jones PM. A novel extract of Gymnema sylvestre improves glucose tolerance in vivo and stimulates insulin secretion and synthesis in vitro. Phytother Res. 2013;27:1006-11. (Studies of ob/ob mice with insulin resistance found that injections of Gymnema sylvestre high molecular weight extracts resulted in improved glucose tolerance tests and administration to isolated mouse islet cells resulted in increased insulin secretion). 22911568
Li Y, Zheng M, Zhai X, Huang Y, Khalid A, Malik A, Shah P, et al. Effect of Gymnema sylvestre, Citrullus colocynthis, and artemisia absinthium on blood glucose and lipid profile in diabetic human. Acta Pol Pharm. 2015;72:981-5. (Among 32 patients with type 2 diabetes, treated in 4 groups [n=8] with 3 different herbs [one being G. sylvestre] or placebo in doses of 500 mg twice daily, those on Gymnema had decreases in fasting glucose levels averaging 37% [from 219 to 138 mg/dL]; no mention of results in the placebo group or of adverse events). 26665406
Zuñiga LY, González-Ortiz M, Martínez-Abundis E. Effect of Gymnema sylvestre administration on metabolic syndrome, insulin sensitivity, and insulin secretion. J Med Food. 2017;20:750-754. (Among 24 adults with obesity and the metabolic syndrome who were treated with G. sylvestre [300 mg] vs placebo twice daily for 12 weeks, body weight deceased slightly [-3.4 kg vs +1.5 kg], but there were minimal changes in fasting blood glucose [-7.2 vs 0 mg/dL] and serum lipids and no change insulin secretion or sensitivity, while adverse events included diarrhea, fever, polydipsia, and abdominal distension but all were transient not requiring dose adjustment or discontinuation and similar in frequency to those receiving placebo). 28459647
Jacobsson I, Jönsson AK, Gerdén B, Hägg S. Spontaneously reported adverse reactions in association with complementary and alternative medicine substances in Sweden. Pharmacoepidemiol Drug Saf 2009; 18: 1039-47. (Review of 778 spontaneous reports of adverse reactions to herbals in a Swedish Registry does not list Gymnema sylvestre among products associated with 5 or more reports). 19650152
Shiyovich A, Sztarkier I, Nesher L. Toxic hepatitis induced by Gymnema sylvestre, a natural remedy for type 2 diabetes mellitus. Am J Med Sci. 2010;340:514-7. (60 year old woman developed fatigue, anorexia, weight loss, and jaundice 17 days after starting an over-the-counter herbal tea that contained Gymnema three times daily [bilirubin 15.9 mg/dL, ALT 760 U/L, Alk P 160 U/L, GGT 273 U/L], biopsy suggesting drug induced injury and ultimate resolution after stopping [Case 1]). 20856101
Teschke R, Wolff A, Frenzel C, Schulze J, Eickhoff A. Herbal hepatotoxicity: a tabular compilation of reported cases. Liver Int 2012; 32: 1543-56. (A systematic compilation of all publications on the hepatotoxicity of specific herbals identified 185 publications on 60 different herbs and herbal supplements but does not list Gymnema sylvestre as a single implicated agent). 22928722
Navarro VJ, Seeff LB. Liver injury induced by herbal complementary and alternative medicine. Clin Liver Dis 2013; 17: 715-35. (Review of the epidemiology, regulatory status, diagnosis, pathogenesis and causes of liver injury from herbal products with specific discussion of conjugated linoleic acid, ephedra, germander, green tea, usnic acid, flavocoxid, aloe vera, chaparral, greater celandine, black cohosh, comfrey, kava, skullcap, valerian, noni juice, pennyroyal, and traditional herbal remedies, but does not mention Gymnema sylvestre). 24099027
Navarro VJ, Barnhart H, Bonkovsky HL, Davern T, Fontana RJ, Grant L, Reddy KR, et al. Liver injury from herbals and dietary supplements in the U.S. Drug-Induced Liver Injury Network. Hepatology 2014; 60: 1399-408. (Among 839 cases of liver injury from drugs collected in the US between 2004 and 2013, 130 were due to HDS products, including 45 from body building agents [probably anabolic steroids] and 85 from diverse HDS products, but no case was attributed specifically to Gymnema sylvestre). 25043597
Pothuraju R, Sharma RK, Chagalamarri J, Jangra S, Kumar Kavadi P. A systematic review of Gymnema sylvestre in obesity and diabetes management. J Sci Food Agric. 2014;94:834-40. (Review of the effects of gymnemic acids on regulation of carbohydrate and lipid metabolism in animals and humans; no discussion of adverse events, ALT levels, or hepatotoxicity). 24166097
Sanematsu K, Kusakabe Y, Shigemura N, Hirokawa T, Nakamura S, Imoto T, Ninomiya Y. Molecular mechanisms for sweet-suppressing effect of gymnemic acids. J Biol Chem. 2014;289:25711-20. (Using an in vitro transfected cell assay, gymnemic acids were found to bind to human sweet taste receptors and inhibit their activation). 25056955
Brown AC. Liver toxicity related to herbs and dietary supplements: online table of case reports. Part 2 of 5 series. Food Chem Toxicol 2017; 107: 472-501. (Description of an online compendium of cases of liver toxicity attributed to HDS products does not list or discuss Gymnema sylvestre). 27402097
Medina-Caliz I, Garcia-Cortes M, Gonzalez-Jimenez A, Cabello MR, Robles-Diaz M, Sanabria-Cabrera J, Sanjuan-Jimenez R, et al.; Spanish DILI Registry. Herbal and dietary supplement-induced liver injuries in the Spanish DILI Registry. Clin Gastroenterol Hepatol. 2018;16:1495-1502. (Among 856 cases of hepatotoxicity enrolled in the Spanish DILI Registry between 1994 and 2016, 32 were attributed to herbal products, the most frequent cause being green tea [n=8] and Herbalife products [n=6]; no mention of Gymnema sylvestre). 29307848
Ballotin VR, Bigarella LG, Brandão ABM, Balbinot RA, Balbinot SS, Soldera J. Herb-induced liver injury: Systematic review and meta-analysis. World J Clin Cases. 2021;9:5490-5513. (Systematic review of the literature on herb induced liver injury identified 446 references describing 936 cases due to 79 different herbal products, the most common being He Shou Wu [91], green tea [90] Herbalife products [64], kava kava [62], and greater celandine [48]; does not mention Gymnema sylvestre). 34307603
Majeed M, Majeed A, Nagabhusahnam K, Mundkur L, Paulose S. A randomized, double-blind clinical trial of a herbal formulation (GlycaCare-II) for the management of type 2 diabetes in comparison with metformin. Diabetol Metab Syndr. 2021;13:132. (Among 69 adults with pre-diabetes or newly diagnosed diabetes treated with a combination product containing 7 herbs including Eurycoma longifolia vs metformin twice daily for 120 days, fasting blood glucose and HbA1c levels improved in both groups to a similar extent and there were “no adverse events reported”, evidently including no change in ALT or AST levels). 34789340
Philips CA, Theruvath AH, Ravindran R. Toxic hepatitis-associated aplastic anaemia after dual homeopathic remedies and Gymnema sylvestre use. BMJ Case Rep. 2022;15:e247867. (50 year old man with diabetes started Gymnema [4 gm daily] and developed itching and jaundice 1 month later [bilirubin 15.6 mg/dL, ALT 79 U/L, Alk P 244 U/L] and while the product was stopped, he developed progressive and fatal aplastic anemia 4 months later; chemical analysis of the herbal product revealed industrial solvents and heavy metals [arsenic and mercury]). 35318201
Bessone F, García-Cortés M, Medina-Caliz I, Hernandez N, Parana R, Mendizabal M, Schinoni MI, et al. Herbal and dietary supplements-induced liver injury in Latin America: experience from the LATINDILI Network. Clin Gastroenterol Hepatol. 2022;20:e548-e563. (Among 367 cases of hepatotoxicity enrolled in the Latin American DILI Network between 2011 and 2019, 29 [8%] were attributed to herbal products, the most frequent being green tea [n=7], Herbalife products [n=5], and garcinia [n=3], while Gymnema sylvestre was not mentioned). 33434654
Kahksha, Alam O, Naaz S, Sharma V, Manaithiya A, Khan J, Alam A. Recent developments made in the assessment of the antidiabetic potential of gymnema species - From 2016 to 2020. J Ethnopharmacol. 2022;286:114908. (Review of recent studies on the mechanism of action and biologically activities of Gymnema sylvestre concludes that the antidiabetic effects of Gymnema are the result of synergistic actions of several components on multiple targets involved in glucose metabolism; no discussion of adverse events). 34906636

## OTHER REFERENCE LINKS

1. Recent References on Gymnema sylvestre: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Gymnema+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Gymnema sylvestre: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Gymnema)